# Streptozocin

## OVERVIEW

### Introduction

Streptozocin is a unique antineoplastic agent used to treat metastatic pancreatic islet cell carcinoma. Streptozocin has been associated with a high rate of serum enzyme elevation during therapy and to rare instances of severe, clinically apparent acute liver injury.

### Background

Streptozocin (strep" toe zoe' sin), which was formerly known as streptotozocin, is an antineoplastic antibiotic isolated initially from Streptomyces achromogenes. Structurally, streptozocin is a methylnitrosourea attached to a single molecule of glucosamine and acts as an alkylating agent causing DNA damage and interfering with synthesis. Streptozocin has high affinity for the cell surface glucose transporter GLUT 2 which is highly expressed on beta cells of the islets of Langerhans. As a consequence, streptozocin has differential toxicity to beta cells. In animal models, streptozocin caused loss of pancreatic islet cells, resulting in a decrease in serum insulin and diabetes. Used initially as a means of creating an animal model of type 1 diabetes, streptozocin was later used clinically to treat insulin-secreting islet cell tumors. It was tried, but had little effect in other malignancies. Streptozocin was approved for use in the chemotherapy of metastatic pancreatic islet cell carcinoma in the United States in 1982 and is still used, but largely in combination with other chemotherapeutic agents such as doxorubicin and fluorouracil. In addition, it has been used off label to treat other neuroendocrine neoplasms. Streptozocin is available as a powder for reconstitution in 1 gram vials under the brand name Zanosar. The typical dose is 500 mg/m^2^ daily for 5 days every 6 weeks or as 1 gram once weekly intravenously until a remission is achieved or significant toxicity intervenes. Common side effects of streptozocin therapy are nausea, vomiting, diarrhea, abdominal discomfort and local infusion site reactions. These immediate reactions can be followed by renal dysfunction (proteinuria, proximal tubular injury, phosphaturia, acute renal failure), bone marrow suppression (anemia, neutropenia) and hepatotoxicity.

### Hepatotoxicity

Serum aminotransferase elevations occur in up to two-thirds of patients treated with streptozocin, but the abnormalities are generally mild, transient and not associated with symptoms or jaundice. Hepatotoxicity is more common with daily dosing and high doses of streptozocin, but with higher doses renal and hematologic toxicities usually overshadow hepatic injury. There have been two reports of rapidly progressive and fatal acute liver failure in patients treated with streptozocin. In one instance, no other chemotherapy was given, in another fluorouracil was coadministered and the patient presented with fever, anuria, acute hepatitis [ALT 1280, bilirubin 11.9, prothrombin index 10%, eosinophils 2600/ µL] at the end of a 5 day course of treatment. In contrast, there have been no individual published case reports of self-limited clinically apparent liver injury attributed to streptozocin, but it has had limited use, as pancreatic islet cell carcinoma and neuroendocrine tumors are rare.

Likelihood score: D (possible cause of clinically apparent liver injury).

### Mechanism of Injury

Like the renal and bone marrow toxicity, the hepatic injury from streptozocin is likely due to a direct effect of the alkylating agent and its limited uptake by hepatocytes. Higher doses have been shown to cause liver injury in experimental animals.

### Outcome and Management

The severity of the liver injury linked to streptozocin therapy has been generally mild, transient and without symptoms or jaundice. Streptozocin has not been linked to cases of chronic hepatitis or vanishing bile duct syndrome. There is no information on cross sensitivity to hepatic injury between streptozocin and other antineoplastic agents.

Drug Class: Antineoplastic Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Streptozocin – Zanosar®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Streptozocin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Streptozocin | 18883-66-4 | C8-H15-N3-O7 | Streptozocin structure

## ANNOTATED BIBLIOGRAPHY

References updated: 23 August 2016

Zimmerman HJ. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity of cancer chemotherapeutic agents published in 1999; mentions that streptozocin can cause elevations in serum aminotransferase levels "but the abnormalities are of little clinical moment").
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam, Elsevier, 2013, p. 541-68. (Review of hepatotoxicity of cancer chemotherapeutic agents; streptozocin is listed as causing transient liver test abnormalities, but not clinically apparent liver injury).
Chabner BA, Bertino J, Cleary J, Ortiz T, Lane A, Supko JG, Ryan DP. Cytotoxic agents. Chemotherapy of neoplastic diseases. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, p. 1698. (Textbook of pharmacology and therapeutics).
Junod A, Lambert AE, Orci L, Pictet R, Gonet AE, Renold AE. Studies of the diabetogenic action of streptozotocin. Proc Soc Exp Biol Med 1967; 126: 201-5. (Studies in rats using purified streptozocin demonstrated a highly specific pancreatic beta cell injury with subsequent decrease in serum insulin levels and development of type 1 diabetes; the authors propose its use to develop animal models of diabetes and as therapy of insulin secreting islet cell tumors). 4864021
Murray-Lyon IM, Eddleston AL, Williams R, Brown M, Hogbin BM, Bennett A, Edwards JC, Taylor KW. Treatment of multiple-hormone-producing malignant islet-cell tumour with streptozotocin. Lancet 1968; 2 (7574): 895-8. (59 year old woman with metastatic, insulin producing islet cell cancer was treated with 3 infusions of streptozocin and achieved a long term remission). 4176152
Taylor SG 3rd, Schwartz TB, Zannini JJ, Ryan WG. Streptozotocin therapy for metastatic insulinoma. Arch Intern Med 1970; 126: 654-7. (70 year old man with metastatic, insulin-producing pancreatic islet cell tumor had a complete remission and correction of hypoglycemia after 5 infusions of streptozocin over a 7 week period). 4319181
Sadoff L. Nephrotoxicity of streptozotocin (NSC-85998). Cancer Chemother Rep 1970; 54 (6): 457-9. (Among 18 patients with various malignancies treated with intravenous streptozocin [2 grams/m2 once weekly], all had some degree of renal tubular toxicity with hypophosphatemia in 14 [5 developing osteomalacia within 6 months], glycosuria in 14, renal tubular acidosis in 10, azotemia in 9, and anuria in 2, one of whom died; 9 patients had AST elevations and 8 hypoalbuminemia "presumably due to liver toxicity"). 4334090
Broder LE, Carter SK. Pancreatic islet cell carcinoma. II. Results of therapy with streptozotocin in 52 patients. Ann Intern Med 1973; 79: 108-18. (Summary of experience using streptozocin for pancreatic islet cell tumors in 52 patients participating in an NCI registry reported a 60% response rate, but toxicities included 7 deaths, 5 from acute renal failure but none from liver injury, despite liver test abnormalities arising in 67% of cases [ALT 16%, AST 27%, Alk P 12%, and bilirubin 4%]; but "hepatic toxicity was difficult to evaluate because most patients had liver metastases"). 4352784
Schein P, Kahn R, Gorden P, Wells S, Devita VT. Streptozotocin for malignant insulinomas and carcinoid tumor. Report of eight cases and review of the literature. Arch Intern Med 1973; 132: 555-61. (Among 8 patients with malignant insulinomas or carcinoid syndrome treated with streptozocin at the NIH Clinical Center, responses occurred only in islet cell tumors and 6 patients had renal toxicity [proteinuria, phosphaturia] which was reversible; and 5 had transient and asymptomatic AST elevations [63-122 U/L]). 4355081
Schein PS, O'Connell MJ, Blom J, Hubbard S, Magrath IT, Bergevin P, Wiernik PH, Ziegler JL, DeVita VT. Clinical antitumor activity and toxicity of streptozotocin (NSC-85998). Cancer 1974; 34: 993-1000. (Among 106 patients with advanced malignancies given streptozocin, responses were not common and limited to lymphomas and islet cell cancer and toxicity included nausea and vomiting [87%] poorly controlled by antiemetics, renal toxicity [28%], and liver enzyme elevations [15%] appearing 1-2 days after the course and rapidly returning to normal without jaundice or symptoms). 4371075
Loftus L, Cuppage FE, Hoogstraten B. Clinical and pathological effects of streptozotocin. J Lab Clin Med 1974; 84: 407-13. (One patient with adenocarcinoma and another with islet cell cancer received multiple courses of streptozocin, one dying of renal failure and the second of progressive disease, both having cellular atypia in the liver on autopsies). 4368506
Herbai G, Lundin A. Treatment of malignant metastatic pancreatic insulinoma with streptozotocin. Review of 21 cases described in detail in the literature and report of complete remission of a new case. Acta Med Scand 1976; 200: 447-52. (55 year old woman with metastatic, insulin secreting islet cell cancer had a remission after 7 infusions of streptozocin; "liver enzyme values and kidney function revealed no abnormalities"). 189576
Hayes JR, O'Connell N, O'Neill T, Fennelly JJ, Weir DG. Successful treatment of a malignant gastrinoma with streptozotocin. Gut 1976; 17: 285-8. (36 year old woman with gastrin producing islet cell tumor did not respond to streptozocin given intravenously, but did after infusions in the celiac artery during which there was a 3 fold increase in ALT). 178577
Meyer DJ. Temporary remission of hypoglycemia in a dog with an insulinoma after treatment with streptozotocin. Am J Vet Res 1977; 38: 1201-4. (7 year old male dog with metastatic insulin secreting pancreatic islet cell tumor developed vomiting followed by proteinuria and liver test abnormalities after a second dose of streptozocin which recurred with another course of treatment [peak ALT 310 and 420 U/L], liver histology at autopsy showing cancer, but no injury to normal liver tissue). 199092
Oberg K, Boström H, Fahrenkrug J, Dymling JF, Shaffalitsky de Muckadell OB, Lundqvist G. Streptozotocin treatment of a pancreatic tumour producing VIP and gastrin associated with Verner-Morrison syndrome. Acta Med Scand 1979; 206: 223-7. (57 year old man with metastatic, gastrin and VIP secreting pancreatic islet cell cancer had a long term remission after 3 weekly infusions of streptozocin [2 g each]; no mention of side effects). 227234
Moertel CG, Hanley JA, Johnson LA. Streptozocin alone compared with streptozocin plus fluorouracil in the treatment of advanced islet-cell carcinoma. N Engl J Med 1980; 303: 1189-94. (Among 84 patients with islet cell cancers treated with streptozocin alone or with fluorouracil, response rates were higher with the combination [63% vs 36%] as was survival, while adverse events included marked nausea and vomiting [85% vs 83%], nephrotoxicity [31% vs 29%] and leukopenia [73% vs 5%] and one patient given streptozocin alone developed acute liver failure immediately after therapy and died on day 18, but no further details provided). 6252466
Weiss RB. Streptozocin: a review of its pharmacology, efficacy, and toxicity. Cancer Treat Rep 1982; 66: 427-38. (Review of the chemistry, pharmacology, efficacy and toxicity of streptozocin mentions that chemical liver dysfunction occurs in 25% of patients, usually 1-2 days after an intravenous course, but the injury is only occasionally severe). 6277485
Luquel L, Ekherian JM, De Gramont A, Offenstadt G. [Anuria, hepatocellular insufficiency and bone marrow aplasia after the administration of streptozocin and fluorouracil]. Therapie 1988; 43: 125. French. (52 year old woman developed fever and anuria between days 4 and 6 of a third 5-day course of streptozocin and fluorouracil with rapidly progressive renal, hematologic and liver failure [bilirubin 11.9 mg/dL, ALT 1280, prothrombin index 10%, eosinophils 2600/µL], resulting in death within 8 days; no autopsy performed). 2970126
Moertel CG, Lefkopoulo M, Lipsitz S, Hahn RG, Klaassen D. Streptozocin-doxorubicin, streptozocin-fluorouracil or chlorozotocin in the treatment of advanced islet-cell carcinoma. N Engl J Med 1992; 326: 519-23. (Among 105 patients with pancreatic islet cell cancer treated with various chemotherapy regimens, streptozocin with doxorubicin yielded the highest rate of tumor regression [69%] and survival rates, while toxicities included severe nausea and vomiting during treatment and delayed renal and hematologic toxicities including one death from sepsis; no mention of ALT elevations or hepatotoxicity). 1310159
Kume E, Fujimura H, Matsuki N, Ito M, Aruga C, Toriumi W, Kitamura K, Doi K. Hepatic changes in the acute phase of streptozotocin (SZ)-induced diabetes in mice. Exp Toxicol Pathol 2004; 55: 467-80. (Study of the direct, acute hepatic toxicity of streptozocin in mice that showed fat droplet accumulation within 24 hours of infusions). 15384252
Aoki T, Kokudo N, Komoto I, Takaori K, Kimura W, Sano K, Takamoto T, et al. Streptozocin chemotherapy for advanced/metastatic well-differentiated neuroendocrine tumors: an analysis of a multi-center survey in Japan. J Gastroenterol 2015; 50: 769-75. (Among 54 patients with neuroendocrine tumors treated with streptozocin at 5 Japanese cancer centers, 13 [24%] had a partial or complete response and "the adverse event profile was mild and tolerable," with mild liver test abnormalities in only one patient). 25348496
Krug S, Boch M, Daniel H, Nimphius W, Müller D, Michl P, Rinke A, et al. Streptozocin-Based Chemotherapy in Patients with Advanced Neuroendocrine Neoplasms--Predictive and Prognostic Markers for Treatment Stratification. PLoS One 2015; 10 (12): e0143822. (Among 77 patients with advanced neuroendocrine tumors seen at a single German referral center between 1995-2013 who were treated with streptozocin with either doxorubicin or fluorouracil [5-FU], the objective response rate was 34% and toxicities were common with serum enzyme elevations in 65% of subjects, which were above 5 times ULN in 5%). 26630134
Clewemar Antonodimitrakis P, Sundin A, Wassberg C, Granberg D, Skogseid B, Eriksson B. Streptozocin and 5-Fluorouracil for the Treatment of Pancreatic Neuroendocrine Tumors: Efficacy, Prognostic Factors and Toxicity. Neuroendocrinology 2016; 103 (3-4): 345-53. (Among 137 patients with neuroendocrine tumors treated with streptozocin and fluorouracil [5-FU] at a Swedish cancer center between 1981 and 2014, 3% had a complete and 25% a partial response while toxicities were "acceptable"; no mention of ALT elevations or hepatotoxicity). 26279284

## OTHER REFERENCE LINKS

1. Recent References on Streptozocin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Streptozocin/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Streptozocin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Streptozocin)